# Lomitapide

## OVERVIEW

### Introduction

Lomitapide is a cholesterol lowering agent that acts by inhibition of the microsomal triglyceride transfer protein and is used to treat the severe lipid abnormalities of familial hypercholesterolemia. Lomitapide is associated with mild, asymptomatic and self-limited serum aminotransferase elevations during therapy that are usually accompanied by an increase in hepatic fat. Long term therapy with lomitapide has been linked to development of steatohepatitis and hepatic fibrosis.

### Background

Lomitapide (loe mi' ta pide) is a potent, orally available inhibitor of the hepatic microsomal triglyceride transfer protein (MTTP) and is used to treat severe forms of familial hypercholesterolemia. MTTP is responsible for transferring triglyceride to apolipoprotein B in the liver which is necessary for the assembly of very low density lipoproteins, the precursors of low density lipoproteins (LDL). Inhibition of apolipoprotein B assembly leads to a marked decrease in circulating LDL cholesterol and triglycerides. Lomitapide is typically used as an adjunct to a low-fat diet and other cholesterol-lowering treatments including statins. Lomitapide was approved for use in the United States in 2012, but its indications were limited to patients with homozygous familial hypercholesterolemia. Use of lomitapide can be associated with serum aminotransferase elevations and increase in hepatic fat. Because of the risk of liver injury, lomitapide is available only as a part of a "Risk Evaluation and Mitigation Strategy" [REMS] that requires regular monitoring of liver tests. Lomitapide is available in capsules of 5, 10, 20, 30, 40 and 60 mg under the trade name Juxtapid. The recommended dose is 5 mg daily initially, with subsequent increases based upon tolerance and effectiveness to a maximum of 60 mg daily. Side effects are not uncommon and include diarrhea, nausea, dyspepsia and abdominal pain that are ameliorated and partially prevented by strict adherence to a low fat diet. Lomitapide can also cause marked drug-drug interactions and increase toxicities of other medications (statins, warfarin, antibiotics). Chronic use of lomitapide can result in fat-soluble vitamin malabsorption and deficiencies.

### Hepatotoxicity

Lomitapide is associated with a moderately high rate of serum aminotransferase elevations during therapy, levels above 3 times the upper limit of normal (ULN) occurring in 34% of patients. Aminotransferase elevations above 10 times ULN have also been reported which can necessitate drug discontinuation. Despite the frequency of ALT elevations, however, increases in serum bilirubin and alkaline phosphatase levels are rare and there have been no reports of clinically apparent acute liver injury with jaundice. Chronic therapy with lomitapide can be associated with fluctuations in serum aminotransferase levels and accumulation of liver fat. In some instances, the increase in liver fat is from baseline levels of <2% to as high as 10% to 40%. At least one instance of steatohepatitis and progressive hepatic fibrosis has been reported in a patient receiving lomitapide long term. The hepatic steatosis is reversed upon stopping lomitapide and generally does not progressively accumulate. The reason why some patients develop liver test abnormalities and accumulate significant amounts of liver fat on lomitapide therapy while others do not, is not clear. The effect is clearly dose related and serum enzyme elevations generally improve with dose modification. The frequency of liver test abnormalities and their association with steatohepatitis led to the requirement for a Risk Evaluation and Mitigation Strategy for lomitapide and it is only available for patients registered in a REMS program.

Likelihood score: C (probable cause of clinically significant liver injury).

### Mechanism of Injury

The cause of hepatic injury from lomitapide appears to be a direct effect of its mechanism of action in inhibiting triglyceride transport out of hepatocytes, which leads to hepatocyte steatosis and, in some instances, liver injury. Lomitapide is also extensively metabolized in the liver, primarily via CYP 3A4 and is very sensitive to inhibitors of this microsomal enzyme. Thus, strong CYP 3A4 inhibitors can cause a marked increase in lomitapide levels. Furthermore, lomitapide can compete with other medications in CYP 3A4 metabolism and cause increases in their levels. Lomitapide is also an inhibitor of P-glycoprotein and can increase the absorption of its substrates.

### Outcome and Management

The ALT elevations associated with lomitapide therapy are not uncommon and are often accompanied by increases in hepatic steatosis which may ultimately lead to steatohepatitis and significant chronic liver injury. The REMS management program calls for dose adjustment or drug discontinuation based upon the degree of serum aminotransferase elevations. Patients receiving lomitapide should also be advised to follow a low fat diet and take fat soluble vitamin supplements. Lomitapide can also cause drug-drug interactions and caution should be used in co-administration of lomitapide with other inhibitors or substrates of CYP 3A4, P-glycoprotein substrates and warfarin.

Drug Class: Antilipemic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lomitapide – Juxtapid®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lomitapide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lomitapide | 182431-12-5 | C39-H37-F6-N3-O2 | Lomitapide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 May 2019

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999, before the availability of lomitapide).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; lomitapide is not discussed).
Gurgle HE, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 605-18. (Textbook of pharmacology and therapeutics).
Cuchel M, Bloedon LT, Szapary PO, Kolansky DM, Wolfe ML, Sarkis A, Millar JS, et al. Inhibition of microsomal triglyceride transfer protein in familial hypercholesterolemia. N Engl J Med 2007; 356: 148-56. (Among 6 patients with familial hypercholesterolemia treated with 4 doses of lomitapide for 4 weeks, LDL cholesterol levels decreased by 51% and triglycerides by 65% at the highest dose and ALT elevations arose in 4 patients, all of whom also had increases in hepatic fat by MRI [10-40%]). 17215532
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 6 due to statins, but none to lomitapide). 20949552
Two new drugs for homozygous familial hypercholesterolemia. Med Lett Drugs Ther 2013; 55 (1413): 25-7. (Concise review of the mechanism of action, efficacy, safety and costs of lomitapide shortly after its approval for use in the US; mentions that it can cause elevations in aminotransferase levels and increases in hepatic steatosis for which reason it is only available through a restricted access program). 23545581
Cuchel M, Meagher EA, du Toit Theron H, Blom DJ, Marais AD, Hegele RA, Averna MR, et al.; Phase 3 HoFH Lomitapide Study investigators. Efficacy and safety of a microsomal triglyceride transfer protein inhibitor in patients with homozygous familial hypercholesterolaemia: a single-arm, open-label, phase 3 study. Lancet 2013; 381 (9860): 40-6. (Among 28 patients with familial hypercholesterolemia treated with escalating doses of lomitapide [5 to 60 mg daily], LDL cholesterol decreased by 50%, but side effects were common, mostly gastrointestinal [>90%] and ALT elevations above 3 times ULN occurred in 10 [36%] and above 5 times ULN in 4 [14%], but none required drug discontinuation and none were associated with jaundice or symptoms, but were accompanied by increases in liver fat [from <2% to ~8%]). 23122768
Raal FJ. Lomitapide for homozygous familial hypercholesterolaemia. Lancet 2013; 381 (9860): 7-8. (Editorial on familial hypercholesterolemia in response to article by Cuchel et al. [2013]). 23122767
Davis KA, Miyares MA. Lomitapide: A novel agent for the treatment of homozygous familial hypercholesterolemia. Am J Health Syst Pharm 2014; 71: 1001-8. (Review of the mechanism of action, efficacy and side effects of lomitapide). 24865757
Rader DJ, Kastelein JJ. Lomitapide and mipomersen: two first-in-class drugs for reducing low-density lipoprotein cholesterol in patients with homozygous familial hypercholesterolemia. Circulation 2014; 129: 1022-32. (Summary of mechanism of action of microsomal triglyceride transport protein [MTTP] inhibitors, their efficacy, adverse event rates, clinical usefulness and need for further research). 24589695
Sacks FM, Stanesa M, Hegele RA. Progression to hepatitis and fibrosis secondary to lomitapide use--reply. JAMA Intern Med 2014; 174: 1522-3. (44 year old woman with severe hypertriglyceridemia and recurrent pancreatitis was treated with lomitapide for 13 years with excellent control of lipid levels, but with fluctuating ALT levels and development of steatohepatitis eventually with significant fibrosis). 25178869
Miyares MA. Progression to hepatitis and fibrosis secondary to lomitapide use: selecting the next course of action. JAMA Intern Med 2014; 174: 1522. (Letter in response to article by Sacks [2014] questioning the use of lomitapide for 13 years in the face of signs of steatohepatitis). 25178868
Cuchel M, Blom DJ, Averna MR. Clinical experience of lomitapide therapy in patients with homozygous familial hypercholesterolaemia. Atheroscler Suppl 2014; 15: 33-45. (Clinical review of efficacy and safety of lomitapide in 29 patients with familial hypercholesterolemia [Cuchel 2013] with in depth discussion of management of side effects including serum ALT elevations). 25257075
Goulooze SC, Cohen AF, Rissmann R. Lomitapide. Br J Clin Pharmacol 2015; 80: 179-81. (Brief review of the mechanism of action and clinical use of lomitapide). 25702706
Roeters van Lennep J, Averna M, Alonso R. Treating homozygous familial hypercholesterolemia in a real-world setting: Experiences with lomitapide. J Clin Lipidol 2015; 9: 607-17. (Details of 4 European patients with familial hypercholesterolemia treated in the "real-world" including one who developed recurrent serum ALT elevations [from 16 to 230 U/L and then from 48 to 132 U/L] and increased liver fat with modest doses of lomitapide [5-10 mg daily], ultimately requiring drug discontinuation). 26228681
Raper A, Kolansky DM, Sachais BS, Meagher EA, Baer AL, Cuchel M. Long-term clinical results of microsomal triglyceride transfer protein inhibitor use in a patient with homozygous familial hypercholesterolemia. J Clin Lipidol 2015; 9: 107-12. (49 year old woman with familial hypercholesterolemia and cardiac complications was treated with lomitapide [40-60 mg daily] and had intermittent ALT elevations [peak ~10 times ULN, but without jaundice or symptoms], but responded to discontinuation and abnormalities did not recur on restarting). 25670368
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 41 cases [5.4%] were attributed to lipid-lowering agents, including 31 due to statins, 5 to niacin and 5 to fibrates, but none to lomitapide). 25754159
Lomitapide (Lojuxta). Use only in homozygous familial hypercholesterolaemia, with caution. Prescrire Int 2015; 24: 176-8. (Commentary on lomitapide stressing its potential for causing liver injury and need to limit its use to patients with homozygous familial hypercholesterolemia). 26240881
Stefanutti C, Morozzi C, Di Giacomo S, Sovrano B, Mesce D, Grossi A. Management of homozygous familial hypercholesterolemia in real-world clinical practice: A report of 7 Italian patients treated in Rome with lomitapide and lipoprotein apheresis. J Clin Lipidol 2016; 10: 782-9. (Description of 7 patients with familial hypercholesterolemia treated with lomitapide, all on lipoprotein apheresis, in whom careful titration of dose was associated with lower rates of gastrointestinal side effects and no patient had to stop therapy because of ALT elevations). 27578108
Sanna C, Stéphenne X, Revencu N, Smets F, Sassolas A, Di Filippo M, Descamps OS, et al. Homozygous familial hypercholesterolemia in childhood: Genotype-phenotype description, established therapies and perspectives. Atherosclerosis 2016; 247: 97-104. (Among 8 patients with familial hypercholesterolemia, all had LDL-cholesterol levels of 500 mg/dL and only modest improvements with use of statins and ezetimibe compared to marked improvements after liver transplantation). 26894473
D'Erasmo L, Cefalù AB, Noto D, Giammanco A, Averna M, Pintus P, Medde P, et al. Efficacy of lomitapide in the treatment of familial homozygous hHypercholesterolemia: results of a real-world clinical experience in Italy. Adv Ther 2017; 34: 1200-10. (Among 15 Italian patients with familial hypercholesterolemia treated with lomitapide, LCL-cholesterol levels fell in all from a mean of 493 to a nadir of 132 mg/dL, and no patient had ALT elevations above 5 times ULN or required discontinuation for liver test abnormalities). 28432645
Chacra APM, Ferrari MC, Rocha VZ, Santos RD. Case report: The efficiency and safety of lomitapide in a homozygous familial hypercholesterolemic child. J Clin Lipidol 2019 Mar 11. pii: [Epub ahead of print] (7.6 year old girl with familial hypercholesterolemia was treated with lomitapide and after 3.5 years LDL-cholesterol levels fell from 428 to 266 mg/dL and ALT and AST levels remained unchanged). 30948303
Ben-Omran T, Masana L, Kolovou G, Ariceta G, Nóvoa FJ, Lund AM, Bogsrud MP, et al. Real-world outcomes with lomitapide use in paediatric patients with homozygous familial hypercholesterolaemia. Adv Ther 2019 May 17. [Epub ahead of print] (Among 11 children at 10 centers in 8 countries treated with lomitapide, LDL-cholesterol levels fell from a mean of 419 to a nadir of 177 mg/dL, and 3 had ALT elevations but were managed with dose adjustment without stopping therapy). 31102204

## OTHER REFERENCE LINKS

1. Recent References on Lomitapide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lomitapide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lomitapide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lomitapide)